# Vorasidenib

## OVERVIEW

### Introduction

Vorasidenib is an orally available, small molecule inhibitor of mutated isocitrate dehydrogenase-1 and -2 (IDH1 and IDH2) that is used in the treatment of brain tumors (astrocytoma and oligodendroglioma) with IDH mutations. Vorasidenib is associated with a high rate of serum aminotransferase elevations during therapy and has been linked to rare instances of clinically apparent liver injury, including an autoimmune-like hepatitis and acute liver failure.

### Background

Vorasidenib (vor” a sid’ e nib) is an orally available, brain penetrant, small molecule inhibitor of the mutated forms of isocitrate dehydrogenase-1 and -2 (IDH1 and IDH2). Isocitrate dehydrogenase is an oxidative decarboxylase in the citric acid cycle, and mutations in IDH1 or IDH2 cause the enzyme to generate an abnormal metabolite, 2-hydroxyglutarate (2-HG), which blocks normal cell differentiation and promotes tumor growth. Mutations in IDH1 or IDH2 are present in most diffuse gliomas. In cell culture and animal models, vorasidenib lowers tumor concentrations of 2-HG and partially restores normal cell differentiation, and, unlike the other agents of this class, it readily crosses the blood-brain barrier, concentrations in brain tumor averaging 1.6 times those in plasma. In a large placebo controlled trial in patients with residual or recurrent IDH-mutant gliomas, vorasidenib doubled progression-free survival. Vorasidenib was approved for use in the United States in 2024 and is currently indicated for the treatment of adults and children 12 years of age and older with grade 2 astrocytoma or oligodendroglioma harboring a susceptible IDH1 or IDH2 mutation; it was the first systemic therapy approved for this indication. Vorasidenib is available in tablets of 10 and 40 mg under the brand name Voranigo. The recommended adult dose is 40 mg once daily, continued until disease progression or unacceptable toxicity; children 12 years and older who weigh less than 40 kg are given 20 mg daily. Common side effects include fatigue, headache, musculoskeletal pain, diarrhea, nausea, and seizures. Laboratory adverse events include elevations in serum ALT, AST, gamma glutamyl transpeptidase (GGT), and alkaline phosphatase, and decreases in neutrophil and platelet counts. Uncommon but potentially severe adverse events include hepatotoxicity and fetal harm. Vorasidenib also lowers blood levels of drugs metabolized by CYP 3A, including some hormonal contraceptives.

### Hepatotoxicity

Vorasidenib is associated with a high rate of serum enzyme elevations during therapy. In the pivotal, prelicensure placebo controlled trial, ALT elevations arose in 59% of vorasidenib-treated patients vs 25% of placebo recipients and were above 5 times ULN in 10% vs none. In the combined prelicensure safety population of 244 patients, ALT elevations arose in 58% of treated patients, alkaline phosphatase in 9%, and bilirubin in 5%. Liver test abnormalities were the dose limiting toxicity in early dose escalation studies which prompted selection of a lower dose for studies of efficacy. The enzyme elevations generally appeared early with a median time to onset or 57 days but a wide range of times from 1 to 1049 days. The abnormalities typically resolved with dose interruption, dose reduction, or stopping. Liver test abnormalities led to dose interruption in 14%, dose reduction in 7%, and permanent discontinuation in 3% of patients.

Two of the 244 patients in the combined safety population developed clinically apparent liver injury and elevations in aminotransferase levels and bilirubin above twice normal. The first was a 45 year old man who developed an autoimmune-like hepatitis 4 months after starting vorasidenib leading to hospitalization and liver biopsy but which eventually resolved approximately 2 months later. The second was a 40 year old man who developed ALT elevations 7 months after starting vorasidenib which worsened despite prompt discontinuation and progressed to severe liver injury. He, nevertheless, ultimately recovered fully within the following two months. Both patients were treated with corticosteroids but without clear-cut evidence of benefit. Since approval and more general use, another case of acute hepatitis has been reported to the sponsor but details have not been published.

Likelihood score: C (probable cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the liver injury from vorasidenib is not known. Vorasidenib is metabolized in the liver and the injury may be due to a toxic or immunogenic intermediate. High doses of vorasidenib demonstrate hepatic toxicity in animals and were associated with high rates of serum aminotransferase elevations in early dose-finding studies in humans. The two cases described in the pre-registration trials of vorasidenib appeared to have idiosyncratic liver injury with features suggestive of immune-mediated injury. Vorasidenib is susceptible to drug-drug interactions with inhibitors and inducers of CYP 1A2; concurrent use of CYP 1A2 inhibitors can increase vorasidenib as much as 2 to 5 fold, which may increase the risk of adverse effects including liver injury.

### Outcome and Management

The serum enzyme elevations that arise during vorasidenib therapy are usually asymptomatic and resolve with temporary interruption or dose reduction, most patients being able to continue treatment. Because clinically apparent injury can be severe, the product label recommends measuring ALT, AST, GGT, alkaline phosphatase, and bilirubin before starting therapy, every 2 weeks for the first 2 months, and monthly thereafter for the first 2 years of treatment. Elevations in ALT or AST above 3 times ULN should lead to temporary discontinuation and resumption at a reduced dose, while values above 20 times ULN, or a recurrence of elevations accompanied by jaundice or symptoms should prompt permanent discontinuation. Whether there is cross sensitivity for hepatic injury among the several IDH1 and IDH2 inhibitors is not known but switching to another agent of this class should be done with caution.

Drug Class: Antineoplastic Agents

Other IDH1 and IDH2 Inhibitors: Enasidenib, Ivosidenib, Olutasidenib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Vorasidenib – Voranigo®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=vorasidenib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Vorasidenib | 1644545-52-7 (https://pubchem.ncbi.nlm.nih.gov/compound/117817422) | C14-H13-Cl-F6-N6 | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 30 July 2026

Abbreviations: 2-HG, 2-hydroxyglutarate; IDH1, isocitrate dehydrogenase-1; IDH2, isocitrate dehydrogenase-2.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999, before the availability of the small molecule isocitrate dehydrogenase inhibitors such as vorasidenib).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 541-67. (Review of the hepatotoxicity of cancer chemotherapeutic agents; the isocitrate dehydrogenase inhibitors are not discussed).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
https://www.accessdata.fda.gov/drugsatfda_docs/nda/2024/218784Orig1s000MultidisciplineR.pdf (Multidisciplinary FDA review of the safety and efficacy of vorasidenib that formed the basis for its approval in 2024 as therapy of IDH-mutant glioma; hepatotoxicity was the predominant safety finding, ALT elevations arising in 58% of the 244 patients treated and being above 5 times ULN in 9%, with two patients developing clinically apparent liver injury with jaundice, one with an autoimmune-like hepatitis and the other with acute liver failure, both of whom recovered slowly but fully after stopping).
Konteatis Z, Artin E, Nicolay B, Straley K, Padyana AK, Jin L, Chen Y, et al. Vorasidenib (AG-881): a first-in-class, brain-penetrant dual inhibitor of mutant IDH1 and 2 for treatment of glioma. ACS Med Chem Lett 2020; 11: 101-7. (Description of the discovery and preclinical characterization of vorasidenib, which penetrated the brain in several species and suppressed 2-hydroxyglutarate production in an animal model with glioma by more than 97%; effects on the liver were not discussed). 32071674
Mellinghoff IK, Penas-Prado M, Peters KB, Burris HA 3rd, Maher EA, Janku F, Cote GM, et al. Vorasidenib, a dual inhibitor of mutant IDH1/2, in recurrent or progressive glioma; results of a first-in-human phase I trial. Clin Cancer Res 2021; 27: 4491-9. 34078652
First-in-human dose escalation study of vorasidenib in 93 patients with IDH-mutant solid tumors including 52 with gliomas; serum aminotransferase elevations were the dose limiting toxicity, arising at daily doses of 100 mg and above, which led to selection of a lower dose for later trials and to designating liver test abnormalities an adverse event of special interest, but no episodes of hepatic failure or autoimmune hepatitis were reported) .
Mellinghoff IK, Lu M, Wen PY, Taylor JW, Maher EA, Arrillaga-Romany I, Peters KB, et al. Vorasidenib and ivosidenib in IDH1-mutant low-grade glioma: a randomized, perioperative phase 1 trial. Nat Med 2023; 29: 615-22. (Among patients with recurrent IDH1-mutant low-grade glioma randomized to vorasidenib, ivosidenib, or no drug for 4 weeks before surgery, both drugs lowered tumor 2-hydroxyglutarate concentrations by roughly 90%, but vorasidenib achieved the greater brain penetration and was selected for phase 3 testing; adverse events were largely mild and included serum aminotransferase elevations). 36823302
Mellinghoff IK, van den Bent MJ, Blumenthal DT, Touat M, Peters KB, Clarke J, Mendez J, et al.; INDIGO Trial Investigators. Vorasidenib in IDH1- or IDH2-mutant low-grade glioma. N Engl J Med 2023; 389: 589-601. (Among 331 patients with residual or recurrent IDH-mutant grade 2 glioma treated with vorasidenib [40 mg daily] or placebo, progression free survival was longer with vorasidenib [median 28 vs 11 months], while ALT elevations were reported in 39% versus 15% of patients and were above 5 times ULN in 10% versus none; supplementary material mentions 3 vorasidenib treated patients with serious hepatic adverse events, one transiently elevated ALT levels, one an autoimmune hepatitis and one hepatic failure, all which resolved with stopping). 37272516
Lamb YN. Vorasidenib: first approval. Drugs 2024; 84: 1325-31. (Summary of the mechanism of action, history of development, pharmacokinetics, efficacy and safety of vorasidenib shortly after its approval in the United States, notes that hepatotoxicity is the principal identified risk and that liver tests should be monitored before and during therapy). 39375303
Vorasidenib (Voranigo) for low-grade glioma. Med Lett Drugs Ther. 2024;66(1715):e188-e189. .39509161
(Concise review of the mechanism of action, clinical efficacy, safety, drug interactions, and costs of vorasidenib shortly after its approval in the United States, mentions that it can cause elevations in serum aminotransferase levels and hepatotoxicity, and that liver tests should be monitored during treatment) .
Lazarev S, Sindhu KK. Vorasidenib: a new hope or a false promise for patients with low-grade glioma? Nat Rev Clin Oncol. 2024;21):835-836. 39266767.
(Commentary discussing the shortcomings of the design and interpretation of the “INDIGO” trial that provided the basis for approval of vorasidenib as therapy of low-grade gliomas with IDH1 or IDH2 mutations, focusing on the lack of a standard-of-care control arm and the modest improvements in the surrogate clinical endpoints that were similar to the improvements with current standard of care regimens for low-grade gliomas).
Barbato MI, Barone AK, Aungst SL, Miller CP, Ananthula S, Bi Y, Yang Y, et al. FDA approval summary: vorasidenib for IDH-mutant grade 2 astrocytoma or oligodendroglioma following surgery. Clin Cancer Res 2025; 31: 4412-8. (FDA summary of the review and approval of vorasidenib on the basis of the controlled trial in 331 patients; hepatotoxicity and embryo-fetal toxicity were the two major safety concerns identified and are the subject of warnings in the product label). 40911439
Cloughesy TF, van den Bent MJ, Touat M, Blumenthal DT, Peters KB, Ellingson BM, Clarke JL, et al. Vorasidenib in IDH1-mutant or IDH2-mutant low-grade glioma (INDIGO): secondary and exploratory endpoints from a randomised, double-blind, placebo-controlled, phase 3 trial. Lancet Oncol 2025; 26: 1665-75. (Longer term analysis of the pivotal trial with an additional 6 months of follow up; vorasidenib slowed tumor growth and improved seizure control without adverse effects on quality of life or neurocognition, and no new safety signals were identified). 41175888

## OTHER REFERENCE LINKS

Recent References on Vorasidenib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Vorasidenib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))

Trials on Vorasidenib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=vorasidenib)